# Move Free

## OVERVIEW

### Introduction

Move Free is a proprietary line of multi-ingredient dietary supplements (MIDS) marketed as aids for joint health and “to help ease joint discomfort, maintain strength and flexibility and help support and nourish cartilage”. The major ingredients in the products include glucosamine, chondroitin, hyaluronic acid and methylsufonylmethane (MSM). There have been several reports of clinically apparent liver injury in patients taking Move Free products; however, the specific ingredient(s) in the various products that might cause liver injury has not been identified and these ingredients may no longer be included in currently available products.

### Background

Move Free is a proprietary product name for an array of multi-ingredient herbal and dietary supplements (MIDS) meant to ease joint discomfort. The Move Free brand is currently produced by Reckitt Benckiser Group plc (Slough, England) which purchased its previous distributor, Schiff Nutrition International (Salt Lake City, UT), in 2012. The constituents of the various Move Free products vary, but are largely glucosamine, chondroitin and hyaluronic acid with various combinations of vitamins (vitamin D3), minerals (boron) and selected nutritional supplements such as krill oil and astaxanthin (a keto-carotenoid anti-oxidant). The ingredients and their concentrations in some of the products have been modified over time. Previous Move Free products have included mixtures of herbal agents including Chinese skullcap (Scutellaria baicalensis) and black catechu (Acacia catechu). Presently, however, Move Free products do not list any herbal constituents although several mention “Uniflex (FruiteX-B Calcium Fructoborate)”.

The common Move Free products that are currently marketed are given in the Table below with a listing of their ingredients as provided in the product labels. Because the products are considered dietary supplements, they are not subject to the usual efficacy and safety evaluation given to medications. However, all nutritional supplements are subject to rules regarding purity and good manufacturing practices. Dietary supplements are not recommended for specific medical conditions, but can be advertised as being supportive of general health or a specific tissue or organ health. These multi-ingredient products appear to be generally safe and well tolerated, but prospective studies of their efficacy, tolerance and safety have not been published.

Selected Move Free Products (February 2016)

Product Name | Condition | Major Listed Ingredients
Move Free Joint Health, Advanced | Joint Health | Glucosamine (1.5 g), Chondroitin (200 mg), Hyaluronic acid (3.3 mg), “Uniflex” FruiteX-B Calcium Fructoborate (216 mg).
Move Free Joint Health, Advanced Plus with MSM | Joint Health | Glucosamine (1.5 g), Chondroitin (200 mg), Methylsulfonylmethane (MSM: 1.5 g), Hyaluronic acid (3.3 mg), “Uniflex” FruiteX-B Calcium Fructoborate (216 mg).
Move Free Joint Health, Advanced Plus MSM & Vitamin D3 | Joint Health | Glucosamine (1.5 g), Chondroitin (200 mg), Methylsulfonylmethane (MSM: 750 mg), Vitamin D3 (2000 IU), Hyaluronic acid (3.3 mg), Uniflex” FruiteX-B Calcium Fructoborate (216 mg).
Move Free Joint Health, Night | Joint Health | Glucosamine (1.5 g), Chondroitin (200 mg), Melatonin (6 mg)
Move Free Ultra Faster Comfort Joint | Joint Comfort | Calcium (35 mg), Calcium fructoborate (216 mg)
Move Free Ultra Tumeric & Tamarind | Joint Comfort | Proprietary Blend (250 mg): Tamarindus indicus (seed) extract and Curcuma longa (rhizome) extract, microcrystalline cellulose
Move Free Ultra, Triple Action | Joint Health | Cartilage Blend (40 mg), Hyaluronic acid (3.3 mg), Boron (5 mg)
Move Free Ultra, Omega | Joint Health | Proprietary Blend (353 mg): Krill oil, Hyaluronic acid, Astaxanthin

### Hepatotoxicity

The initial reports of liver injury attributed to Move Free were published in 2010, with subsequent reports in 2012 and 2013, all from the United States. These publications described an acute hepatocellular injury arising within 1 to 3 weeks of starting a Move Free product that contained glucosamine, chondroitin and a proprietary herbal mixture of Chinese skullcap (Scutellaria baicalensis) and black catechu (Acacia catechu). The injury was moderate in severity and resolved within 1 to 2 months of stopping the supplement. Immunoallergic and autoimmune features were not present, and the injury resolved without residual in all cases. One patient restarted the product after at least partial recovery and redeveloped a similar pattern of liver injury. While further cases have not been described, prospective studies of drug induced liver injury from the United States mentioned 3 cases of acute liver injury linked to Move Free products, all from 2012-2013. At present, Move Free products do not list a proprietary herbal component but do mention a proprietary mineral complex with a similar name: “Uniflex”.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury attributed to Move Free products has been reported to be due to Chinese skullcap, but the mechanism by which this herb might cause liver injury is unexplained. Indeed, Chinese skullcap has hepatoprotective activity in animal models of liver disease. Contamination or misidentification of the herbal components is always a possibility in explaining the appearance of liver injury.

### Outcome and Management

The liver injury that has been attributed to Move Free products has usually been mild-to-moderate in severity and self-limited in course, resolving in 1 to 2 months of stopping the preparations. Move Free has not been linked to instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. In patients presenting with acute, unexplained liver injury, all HDS products should be discontinued and the case reported to federal registries. It is also helpful to carefully define what products were being taken and at what doses and for how long. Retrieval of the actual product or products can also be helpful as progress is being made in the identification of ingredients by advanced chemical and biochemical methods.

Drug Class: Herbal and Dietary Supplements, Nutritional Supplements, Multi-Ingredient

## CASE REPORT

### Case 1. Repeated episodes of acute hepatitis after use of Move Free.(1)

A 78 year old woman osteoarthritis developed jaundice within 3 weeks of starting “Move Free Advanced”, a proprietary multi-ingredient nutritional supplement advertised to be helpful for joint discomfort. She had no history of liver disease, but had a previous cholecystectomy. She denied alcohol abuse and risk factors for viral hepatitis. She was taking no other medications except for multivitamins. On presentation, serum bilirubin was 7.2 mg/dL, ALT 1626 U/L, AST 1053 U/L, alkaline phosphatase 354 U/L and GGT 599 U/L. Tests for hepatitis A, B and C were negative. She was hospitalized and the Move Free product was stopped. She began to improve without specific therapy and was discharged after a few days (Table). Because her joint symptoms worsened, she restarted the Move Free product and redeveloped jaundice within two weeks. Her laboratory tests were again abnormal in a pattern similar to the initial episode. A liver biopsy showed acute hepatocellular injury with many eosinophils suggestive of drug induced liver injury. Tests for autoantibodies were negative and a CT scan of the abdomen showed no evidence of biliary obstruction or hepatic masses. At this point, the nutritional supplement was suspected to be the cause and was found to be Move Free Advanced and have glucosamine, chondroitin and two herbal ingredients, Chinese skullcap and black catechu listed together as “Uniflex Proprietary Extract: 200 mg”. She was told to avoid its further use and in follow up her symptoms resolved and liver tests improved.

#### Key Points

Medication: | Move Free Advanced
Pattern: | Hepatocellular (R=10)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks initially, 2 weeks on rechallenge
Recovery: | Not specified
Other medications: | Multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 weeks | 0 | 1626 | 354 | 7.2 | Presentation
5 weeks | 2 weeks | 678 | 279 | 2.3 | Asymptomatic
| | Move Free Advanced restarted
2 weeks | 0 | 1206 | 286 | 4.7 | Symptomatic
6 weeks | 4 weeks | 120 | 126 | 0.9 | Asymptomatic
Normal Values | | <60 | <132 | <1.2

#### Comment

An elderly woman with osteoarthritis developed an acute hepatitis a few weeks after starting an herbal and dietary supplement called “Move Free Advanced” that was thought to contain glucosamine and chondroitin only, neither of which are considered hepatotoxic. No other cause for the hepatitis was identified, and her physicians assured her that glucosamine and chondroitin were not the reason for the liver injury. Upon restarting the multi-ingredient nutritional supplement, however, she redeveloped jaundice. On closer inspection, the product label of Move Free Advanced also listed a “proprietary” mixture of herbal agents which included Chinese skullcap (Scutellaria baicalensis) and black catechu (Acacia catechu). Chinese skullcap had been implicated in rare cases of drug induced liver injury, although the association was not completely convincing. The recurrence of injury with a similar latency and pattern of enzyme elevations is very convincing evidence that the nutritional supplement was the likely cause of the episode, but the specific ingredient responsible is somewhat unclear and the injury may have been due to a contaminant or misidentified constituent in the proprietary mixture. Current formulations of Move Free products do not mention Chinese skullcap as an ingredient.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Move Free®

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Move+Free)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chondroitin | 9007-27-6 | (C14-H21-N-O12)n-
Glucosamine | 3416-24-8 | C6-H13-N-O5
Hyaluronic Acid | 9004-61-9 | Unspecified

## CITED REFERENCE

1 Yang L, Aronsohn A, Hart J, Jensen D. (2012). Herbal hepatoxicity from Chinese skullcap: A case report. World J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 26 February 2020

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; Move Free products, glucosamine, chondroitin and hyaluronic acid are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; does not mention Move Free products, glucosamine, chondroitin or hyaluronic acid).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for HDS, but the specific herbs and products implicated were not listed).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to HDS, but no Move Free product was implicated).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to HDS to a Swedish Registry found 31 with increased liver enzymes, 26 with elevated aminotransferase levels, 22 with mixed liver reaction and 12 with hepatitis; agents implicated in causing liver injury included valerian, ginseng, green tea, and aloe vera; glucosamine, chondroitin, skullcap, black catechu and Move Free products were not specifically mentioned).
Linnebur SA, Rapacchietta OC, Vejar M. Hepatotoxicity associated with Chinese skullcap contained in Move Free Advanced dietary supplement: two case reports and review of the literature. Pharmacotherapy 2010; 30(7): 750, 258e-262e. (2 cases: 71 and 85 year old women with osteoarthritis developed fatigue a week after starting a Move Free product [containing Chinese skullcap] and were later found to have abnormal liver tests [peak bilirubin 2.0 and 0.2 mg/dL, ALT 650 and 54 U/L, Alk P 310 and 144 U/L], which resolved with 4-8 weeks of stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to HDS, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut; Move Free products were not mentioned).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; no mention of Move Free, glucosamine, chondroitin or Chinese skullcap).
Yang L, Aronsohn A, Hart J, Jensen D. (2012). Herbal hepatoxicity from Chinese skullcap: A case report. World J Hepatol. (78 year old woman with osteoarthritis developed jaundice 3 weeks after starting Move Free Advanced [bilirubin 7.2 mg/dL, ALT 1626 U/L, Alk P 354 U/L] which resolved on stopping, but recurred when she restarted the product [bilirubin 4.7 mg/dL, ALT 1206 U/L, Alk P 286 U/L], the product containing glucosamine and chondroitin but also “Uniflex Proprietary Extract” of Chinese skullcap and black catechu: Case 1).
Dhanasekaran R, Owens V, Sanchez W. (2013). Chinese skullcap in move free arthritis supplement causes drug induced liver injury and pulmonary infiltrates. Case Reports Hepatol. (62 year old woman developed shortness of breath and jaundice two weeks after starting a Move Free product [containing Chinese skullcap] with pulmonary infiltrates and abnormal liver tests [bilirubin 6.9 mg/dL, ALT 1247 U/L, Alk P 297 U/L], both liver and pulmonary abnormalities resolving within 8 weeks of stopping).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that skullcap has been implicated in several cases of liver injury).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to a Move Free product or Chinese skullcap).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix; no mention of glucosamine, chondroitin, Chinese skullcap or Move Free products).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions cases of liver injury attributed to Chinese skullcap, three of which were components of Move Free products).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, two [2.3%] were attributed to Move Free products).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions several cases that have implicated Move Free products, most likely due to Chinese skullcap, although a single case report has implicated glucosamine).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; does not discuss Move Free products).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that multi-ingredient supplements have been implicated in many cases of liver injury including proprietary agents marketed under the names Herbalife, Hydroxycut and OxyELITE Pro; Move Free products are not mentioned).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS mentions that Herbalife has been implicated in 54 cases of liver injury, 7 with a positive rechallenge, but that the cause of the injury remains unknown and that few cases have been published since 2011; does not mention Move Free products).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], of which 2 were attributed to Move Free products: see Navarro, Barnhart et al. [2014]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci. (Tabular listing of implicated dietary supplements in published cases of liver injury does not mention glucosamine, chondroitin, Move Free or Chinese skullcap).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions 2 cases that were attributed to Move Free which contained glucosamine and Skullcap [Linnebur 2010, Yang 2012]).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al. (2018). Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of drug induced liver injury enrolled in a Spanish registry between 1994 and 2016, 32 were due to an HDS including 7 attributed to green tea, 6 to Herbalife products, 2 to valerian, and 2 to cascara Sagrada, but none to a Move Free product).

## OTHER REFERENCE LINKS

1 Recent References on Move Free: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Move+Free%2FAE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D))
2 Trials on Move Free: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Move%20Free)